# Pyrimidine Analogues

## OVERVIEW

The pyrimidine analogues, used as antineoplastic agents, are a diverse group of agents with similar structures but somewhat different mechanisms of action, activities and spectra of activity. These agents are nucleoside analogues and are considered antimetabolites, interfering or competing with nucleoside triphosphates in the synthesis of DNA or RNA or both. The agents are analogues of cytosine (azacitidine, decitabine, cytarabine, gemcitabine) or uracil (fluorouracil, floxuridine, capecitabine), and demonstrate a range of antineoplastic activity in cell and animal models. Azacitidine and decitabine have unique actions in that they block or decrease the methylation of cytosine and, thus, cause hypomethylation of DNA and increased gene expression. Because some cancers are marked by hypermethylation of tumor suppressor genes, azacitidine and decitabine have a potential for specific anticancer activity in these conditions. These two agents are used predominantly in the therapy of myelodysplasia. In contrast, fluorouracil (5-FU) and floxuridine (FUDR) have more typical antineoplastic activity and are important agents in regimens for several solid tumors. Capecitabine is an orally available, prodrug of fluorouracil and has activity against a similar spectrum of cancers as fluorouracil. Cytarabine (Ara-C) and gemcitabine are cytosine analogues, but are used in different forms of cancer, cytarabine for leukemias and lymphomas and gemcitabine in solid tumor chemotherapy.

All of the pyrimidine analogues have some degree of direct hepatotoxic potential. In the doses and regimens in current use, this hepatotoxicity is generally mild and manifested only by frequent, mild and transient serum aminotransferase elevations. For many of these agents, however, more clinically apparent liver injury has been described, particularly with fluorouracil and cytarabine. Two pyrimidine analogues have been linked to unique forms of liver injury. Fluorouracil, when given in high doses, can induce the rapid onset of hyperammonemia and coma. While this syndrome is probably mediated by hepatic dysfunction, it is generally rapidly reversible and not associated with jaundice or acute liver injury. A second unique pattern of injury occurs with hepatic artery infusions of floxuridine, which can cause scarring and inflammation of the gallbladder and bile ducts manifested by acute, acalculous cholecystitis or by severe, high grade biliary strictures. This injury appears to be due to exposure of biliary ducts to high concentrations of FUDR given in the hepatic artery, which is the predominant blood supply of the bile ducts. The injury does not occur with systemic or even portal administration of FUDR. Fluorouracil can also cause biliary injury and strictures, but much less commonly (generally in <1% of treated patients) than floxuridine (arising in 5% to 25%).

Drug Class: Antineoplastic Agents

Drugs in the Subclass, Pyrimidine Analogues: Azacitidine, Capecitabine, Cytarabine, Decitabine, Floxuridine, Fluorouracil, Gemcitabine, Trifluridine/Tipracil